# Fludarabine

## OVERVIEW

### Introduction

Fludarabine is a purine analogue and antineoplastic agent used in the therapy of chronic lymphocytic leukemia (CLL) and in immunosuppressive regimens in preparation of hematopoietic cell transplantation (HCT). Fludarabine is associated with a low rate of transient serum enzyme elevations during therapy and has only rarely been implicated in cases of clinically apparent acute liver injury with jaundice. Fludarabine has potent immunosuppressive activity and has been associated with many cases of reactivation of hepatitis B.

### Background

Fludarabine (floo dar' a been) phosphate is a purine analogue that is used commonly in the treatment of chronic lymphocyte leukemia. Fludarabine phosphate is a fluorinated derivative of the antiviral agent adenine arabinoside monophosphate (2-fluoro-ara-AMP). Fludarabine is converted intracellularly to the active triphosphate, which competes with adenine triphosphate for use by DNA polymerase leading to inhibition of DNA synthesis. Fludarabine was found to have activity against several forms of leukemia and lymphoma and was approved for use as an antineoplastic agent in the United States in 1991. Current indications are therapy of chronic lymphocyte leukemia. Fludarabine is also used off-label for hairy cell leukemia, mycosis fungoides, and both Hodgkin and non-Hodgkin lymphomas as well as in immunosuppressive regimens for nonmyeloablative hematopoietic cell transplantation (HCT). Fludarabine is available as a powder or solution for injection generically and under the trade name Fludara. Oral formulations are also available as tablets of 10 mg generically and under the trade name Oforta. The typical adult dose for CLL is 25 mg/m^2^ intravenously or 40 mg/m^2^ orally each day for 5 days; each 5 day course given is every 28 days. The dose regimen for nonmyeloablative HCT is typically 30 mg/m^2^ intravenously for 3 days in the week before transplant, usually in combination with total body irradiation or other alkylating agents. Common side effects include bone marrow suppression, leucopenia, infections, fever, nausea, vomiting, anorexia, diarrhea, headache, fatigue and skin rash.

### Hepatotoxicity

In clinical trials, serum enzymes elevations occurred in only a small proportion of patients treated with fludarabine for leukemia. The role of fludarabine as opposed to other antineoplastics used in antileukemic regimens was not always clear from these studies. Cases of clinically apparent liver injury due to fludarabine have been reported to occur, but few details were available and most patients were receiving other cancer chemotherapeutic agents.

Fludarabine is immunosuppressive and decreases total white blood cell counts and specifically lymphocyte counts and CD8 T cells. As a consequence, fludarabine therapy has been linked to cases of reactivation of chronic hepatitis B, including instances of reverse seroconversion marked by development of HBsAg and active disease in a patient who had resolved hepatitis B before chemotherapy, as shown by presence of anti-HBc without HBsAg. Reactivation typically occurs after 3 to 6 courses of anticancer mediations and most commonly 2 to 4 months after completing chemotherapy. The frequency and severity of reactivation after fludarabine therapy has led to recommendations that patients be screened for HBsAg and anti-HBc before treatment, and give prophylaxis with antiviral therapy using an oral nucleoside with potent activity against HBV, such as lamivudine, tenofovir or entecavir. If prophylaxis is not used, careful monitoring and early institution of antiviral therapy is warranted. Fludarabine has also been associated with development of opportunistic infections including herpes virus and adenovirus infection of the liver.

Likelihood score: E* (Unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatotoxicity from fludarabine is likely due to direct toxicity. Reactivation of hepatitis B is likely due to the immunosuppressive activity of fludarabine. The specific role of fludarabine in situations in which patients also receive corticosteroids, rituximab or HCT cannot always be determined.

### Outcome and Management

The severity of the liver injury linked to fludarabine therapy is generally self-limited and mild, and resolves with stopping therapy. Reactivation of hepatitis B, in contrast, can be severe and lead to acute liver failure and death.

Drug Class: Antineoplastic Agents, Antimetabolites

Other Drugs in the Subclass, Purine Analogues: Azathioprine, Cladribine, Clofarabine, Mercaptopurine, Nelarabine, Pentostatin, Thioguanine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fludarabine (Injectable) – Generic, Fludara®

Fludarabine (Oral) – Generic, Oforta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fludarabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fludarabine | 21679-14-1 | C10-H12-F-N5-O4 | Fludarabine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 February 2018

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that fludarabine and cladribine were newly developed antineoplastic purine analogues and had yet to be implicated in causing liver injury).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of hepatotoxicity of anticancer agents does not discuss fludarabine).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Purine analogs. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1701-5. (Textbook of pharmacology and therapeutics).
Harvey WH, Fleming TR, Beltran G, Saiers JH, Oishi N, Von Hoff DD. Phase II study of fludarabine phosphate in previously untreated patients with hepatoma: a Southwest Oncology Group Study. Cancer Treat Rep 1987; 71: 1111-2. (Among 19 patients with hepatocellular carcinoma treated with fludarabine [25 mg/m^2^/day for 5 days every 28 days], none had a clinical response and side effects were limited to myelosuppression, somnolence, peripheral neuropathy, nausea, vomiting, diarrhea and rash; no mention of ALT elevations or hepatotoxicity). 2445482
Harvey WH, Fleming TR, Von Hoff DD, Katterhagen JG, Coltman CA Jr. Phase II study of fludarabine phosphate in previously untreated patients with colorectal carcinoma: a Southwest Oncology Group Study. Cancer Treat Rep. 1987; 71: 1319-20. (Among 20 patients with advanced colorectal carcinoma treated with fludarabine [25 mg/m^2^/day for 5 days every 28 days], none had a clinical response and side effects were limited to myelosuppression, somnolence, nausea, vomiting, diarrhea and rash; no mention of ALT elevations or hepatotoxicity). 2446754
Keating MJ, Kantarjian H, Talpaz M, Redman J, McCredie KB. Fludarabine therapy in chronic lymphocytic leukemia (CLL). Nouv Rev Fr Hematol 1988; 30 (5-6): 461-6. (Among 75 previously treated patients with CLL who were treated with fludarabine, 56% had a partial or complete response and the major toxicities were infections, leucopenia, neuropathy, nausea, stomatitis and diarrhea; no mention of ALT elevations or hepatotoxicity). 2464794
Keating MJ, Kantarjian H, Talpaz M, Redman J, Koller C, Barlogie B, Velasquez W, et al. Fludarabine: a new agent with major activity against chronic lymphocytic leukemia. Blood 1989; 74: 19-25. (In preliminary studies of fludarabine in 68 previously treated patients with CLL, 56% had a partial or complete response and the major toxicities were myelosuppression and infections; one patient stopped therapy early because of "hepatitis"). 2473795
Chun HG, Leyland-Jones B, Cheson BD. Fludarabine phosphate: a synthetic purine antimetabolite with significant activity against lymphoid malignancies. J Clin Oncol 1991; 9: 175-88. (Review of results of treating more than 1500 patients with various malignancies with fludarabine, found promising results in chronic lymphocytic leukemia but little activity in common solid tumors; toxicities included myelosuppression and occasional elevations in serum aminotransferase levels). 1702143
O'Brien S, Kantarjian H, Beran M, Koller C, Talpaz M, Lerner S, Keating MJ. Fludarabine and granulocyte colony-stimulating factor (G-CSF) in patients with chronic lymphocytic leukemia. Leukemia 1997; 11: 1631-5. (Among 25 adults with CLL treated with fludarabine [30 mg/m^2^ daily for 5 days, 1-9 courses] and G-CSF [starting on day 6], rates of neutropenia were less compared to historical controls, but rates of response and infection, except for pneumonia, were not different; no mention of ALT elevations or liver injury). 9324281
Hogan WJ, Edwards WD, Macon WR, Habermann TM. Fulminant hepatic failure secondary to adenovirus following fludarabine-based chemotherapy for non-Hodgkin's lymphoma. Leuk Lymphoma 2001; 42: 1145-50. (54 year old man with non-Hodgkin lymphoma developed fever followed by respiratory and hepatic failure shortly after a third cycle of fludarabine and cyclophosphamide [bilirubin 6.5 mg/dL, AST 8838 U/L, Alk P 304 U/L], autopsy showing massive hepatic necrosis and presence of large intranuclear viral inclusions shown to harbor adenovirus by in situ hybridization). 11697635
Ng HJ, Lim LC. Fulminant hepatitis B virus reactivation with concomitant listeriosis after fludarabine and rituximab therapy: case report. Ann Hematol 2001; 80 (9): 549-52. (53 year old woman with CLL and HBsAg carrier state developed jaundice and acute HBV reactivation 6 months after finishing 6 courses of fludarabine and cyclophosphamide, and 2 months after receiving 4 doses of rituximab [bilirubin 10.8 mg/dL, ALT 1479 U/L, Alk P 147 U/L, HBV DNA positive], with progressive liver failure, sepsis and death 12 days after presentation). 11669307
Picardi M, Pane F, Quintarelli C, De Renzo A, Del Giudice A, De Divitiis B, Persico M, et al. Hepatitis B virus reactivation after fludarabine-based regimens for indolent non-Hodgkin's lymphomas: high prevalence of acquired viral genomic mutations. Haematologica 2003; 88: 1296-303. (Among 40 patients with non-Hodgkin lymphoma treated with fludarabine, reactivation of hepatitis B occurred in all 4 who were HBsAg positive before therapy, but in only 1 of 8 who had anti-HBc, anti-HBs or anti-HBe without HBsAg, arising after 4-16 weeks after completing therapy [peak bilirubin 6-22 mg/dL, ALT 800-2000 U/L], 2 dying and 3 recovering, all three becoming HBsAg negative). 14607759
Hogan WJ, Maris M, Storer B, Sandmaier BM, Maloney DG, Schoch HG, Woolfrey AE, et al. Hepatic injury after nonmyeloablative conditioning followed by allogeneic hematopoietic cell transplantation: a study of 193 patients. Blood 2004; 103: 78-84. (Among 193 patients treated with nonmyeloablative HCT for malignancy 74% of whom received fludarabine [30 mg/m^2^ for 3 days], 51 [26%] developed jaundice [bilirubin >4 mg/dL] which was attributed to graft-vs-host disease [41%], sepsis, cyclosporine toxicity, hemolysis, ischemia, or metastases). 12969980
Diaconescu R, Flowers CR, Storer B, Sorror ML, Maris MB, Maloney DG, Sandmaier BM, et al. Morbidity and mortality with nonmyeloablative compared with myeloablative conditioning before hematopoietic cell transplantation from HLA-matched related donors. Blood 2004; 104: 1550-8. (Comparison of 73 patients undergoing nonmyeloablative to 73 undergoing ablative preparation for HCT found a lower rate of severe hepatic toxicity after nonablative [16%, no sinusoidal obstruction syndrome:SOS] than ablative [31%; 18% SOS] regimens). 15150081
Huynh T, Mansberg R, Hsiao E, Coyle L, Roach P. Transient absence of hepatic uptake on gallium-67 scintigraphy following fludarabine therapy. Clin Nucl Med 2004; 29: 275-6. (61 year old man with CLL developed fever and abnormal liver tests [no details provided] 2 weeks after finishing fludarabine therapy and had transient lack of hepatic update of gallium by scintigraphy, restored after 5 days). 15096981
Kusumi E, Kami M, Kanda Y, Murashige N, Seki K, Fujiwara M, Koyama R, et al. Hepatic injury following reduced intensity unrelated cord blood transplantation for adult patients with hematological diseases. Biol Blood Marrow Transplant 2006; 12: 1302-9. (Among 104 adults undergoing reduced intensity preparation for HCT, 87% developed hyperbilirubinemia, but the abnormalities were not attributed to fludarabine, but rather graft-vs-host disease, cholangitis lenta, sepsis, concurrent drug therapy, disease progression and liver congestion). 17162212
Wasmuth JC, Fischer HP, Sauerbruch T, Dumoulin FL. Fatal acute liver failure due to reactivation of hepatitis B following treatment with fludarabine/cyclophosphamide/rituximab for low grade non-Hodgkin's lymphoma. Eur J Med Res 2008; 13: 483-6. (55 year old man with non-Hodgkin lymphoma and "past history of hepatitis B" developed jaundice two months after completing 6 cycles of rituximab, fludarabine and cyclophosphamide [bilirubin 5.9 rising to 29.7 mg/dL, ALT 271 rising to 1374 U/L, Alk P 73 rising to 214 U/L, HBsAg, HBeAg and HBV DNA positive], dying of hepatic failure 1 month after presentation). 19008178
Sanchez MJ, Buti M, Homs M, Palacios A, Rodriguez-Frias F, Esteban R. Successful use of entecavir for a severe case of reactivation of hepatitis B virus following polychemotherapy containing rituximab. J Hepatol 2009; 51: 1091-6. (62 year old man with CLL developed reverse seroconversion and reactivation of hepatitis B after 4 rounds of chemotherapy with fludarabine, cyclosphosphamide and rituximab [bilirubin 10.3, ALT 3481 U/L, INR 1.8, HBsAg, and HBV DNA positive], treated with entecavir and ultimately resolving the hepatitis B with loss of HBsAg). 19836097
Power JP, El Chaar M, Temple J, Thomas M, Spillane D, Candotti D, Allain JP. HBV reactivation after fludarabine chemotherapy identified on investigation of suspected transfusion-transmitted Hepatitis B virus. J Hepatol 2010; 53: 780-7. (54 year old man with CLL and previous hepatitis B was treated with fludarabine and developed reverse seroconversion [bilirubin 1.7 mg/dL, ALT 104 U/L, HBsAg and HBeAg positive], resolving in follow up with clearance of HBsAg and development of anti-HBs). 20638744
Pai RK, van Besien K, Hart J, Artz AS, O'Donnell PH. Clinicopathologic features of late-onset veno-occlusive disease/sinusoidal obstruction syndrome after high dose intravenous busulfan and hematopoietic cell transplant. Leuk Lymphoma 2012; 53: 1552-7. (Clinical description of 8 patients with delayed SOS after HCT using conditioning with busulfan, fludarabine and alemtuzumab with onset 37-77 days after transplant [peak bilirubin 1.3-22.9 mg/dL], most dying of persistent disease or SOS). 22280517
Freedberg DE, Bhadelia N, Poneros JM, Oster MW. Visceral varicella in a patient with chronic lymphocytic leukemia treated with fludarabine: a case report. Clin Lymphoma Myeloma Leuk 2013; 13: 90-2. (54 year old man with CLL on fludarabine therapy developed varicella-zoster with involvement of intestine, pancreas and liver including ALT elevations [twice ULN], resolving with valacyclovir therapy). 23103084
Ronan BA, Agrwal N, Carey EJ, De Petris G, Kusne S, Seville MT, Blair JE, Vikram HR. Fulminant hepatitis due to human adenovirus. Infection 2014; 42: 105-11. (70 year old woman with CLL treated with fludarabine, rituximab and prednisone developed fever and rising liver tests [bilirubin rising to 5.4 mg/dL, ALT 1699 U/L, Alk P 173 U/L], progressing to multiorgan failure and death; autopsy showed adenovirus hepatitis by in situ hybridization). 23979854
Chen S, Osborn JD, Chen X, Boyer MW, McDonald GB, Hildebrandt GC. Subacute hepatic necrosis mimicking veno-occlusive disease in a patient with HFE H63D homozygosity after allogeneic hematopoietic cell transplantation with busulfan conditioning. Int J Hematol 2015; 102: 729-31. (31 year old man with myelodysplasia underwent hematopoietic cell transplanation after myeloablation using busulfan and fludarabine and developed fever and liver injury 23 days after transplant [bilirubin 1.3 mg/dL, ALT 1339 U/L, Alk P 84 U/L, INR 1.3], and SOS on liver biopsy, resolving within the following 2 weeks). 26497867
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, anticancer agents accounted for 49 cases [6%] but none were attributed to fludarabine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Fludarabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fludarabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fludarabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fludarabine)